# Abemaciclib

## OVERVIEW

### Introduction

Abemaciclib is a unique cyclin-dependent kinase inhibitor that is used in combination with an antiestrogen in the treatment of postmenopausal women with metastatic breast cancer. Abemaciclib is associated with a moderate rate of serum aminotransferase elevations during therapy and has been linked to rare cases of clinically apparent liver injury.

### Background

Abemaciclib (a bem" a sye' klib) is an orally available, small molecule inhibitor of cyclin-dependent kinases (CDK) 4 and 6 that is used in combination with fulvestrant in the therapy of postmenopausal women with metastatic breast cancer that is positive for the estrogen receptor (ER) but negative for human epidermal growth factor receptor 2 (HER2). The cyclin kinases 4 and 6 regulate the cellular transition from the G1 to the S phase of the cell cycle acting through the retinoblastoma protein (Rb) pathway. Inhibition of this transition blocks the progression of the cell cycle and results in growth arrest in rapidly dividing cells. Components of this pathway are often mutated or overexpressed in cancer cells. In several clinical trials, the addition of abemaciclib to fulvestrant (a steroidal antiestrogen) therapy of metastatic breast cancer (ER+, HER2-) in postmenopausal women was associated with a prolongation of disease-free survival. As monotherapy, abemaciclib was also found effective in adult patients with refractory, metastatic HR+, HER2- breast cancer. Abemaciclib received accelerated approval for these indications in the United States in 2017, the third CDK 4/6 inhibitor approved as therapy of breast cancer, following palbociclib (Ibrance: 2015) and ribociclib (Kisqali: 2017). Abemaciclib is also under investigation as therapy of several solid tumors and lymphomas, but the initial indications were limited to metastatic ER+, HER2- breast cancer in postmenopausal women. Abemaciclib is available in tablets of 50, 100, 150 and 200 mg under the brand name Verzenio, and the initial recommended dose is 150 mg twice daily in combination with fulvestrant or 200 mg twice daily if used alone, continued indefinitely or until there is disease progression or unacceptable toxicity. Common side effects include diarrhea, neutropenia, fatigue, nausea, anorexia, thrombocytopenia, headache and back pain. Less common but potentially severe adverse reactions include venous thromboembolism, severe neutropenia, fever, neutropenic sepsis, infections and embryo-fetal toxicity.

### Hepatotoxicity

In the large clinical trials, adverse events were common and led to dose reductions in up to one-half of patients and discontinuation in 9%. In preregistration clinical trials, ALT elevations occurred in 31% to 41% of abemaciclib treated subjects which were above 5 times the ULN in 3% to 5%. In one study, several recipients developed clinically apparent liver injury with jaundice and one recipient died of hepatic failure, but these outcomes were considered to be unrelated to abemaciclib therapy. Thus, there were no cases of clinically apparent liver injury that could be attributed to abemaciclib therapy during prelicensure studies. Since the approval and more widescale use of abemaciclib, there have been several published reports of its hepatotoxicity. Most reports of liver injury from abemaciclib are marked by prominent serum aminotransferase elevations (5 to 20 times ULN) with minimal bilirubin elevations and few symptoms arising 1 to 3 months after initiation of therapy, and with rapid resolution upon stopping abemaciclib. In several cases there was rapid recurrence on restarting, but subsequent tolerance without serum enzyme elevations upon switching to other cyclin-dependent kinase inhibitors such as palbociclib or ribociclib. Isolated cases of liver injury with jaundice and severe outcomes including fatalities attributed to abemaciclib have been reported but are rare.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations and liver injury from abemaciclib therapy are not known. Abemaciclib is extensively metabolized in the liver largely through the cytochrome P450 CYP 3A4 isoenzyme and liver injury might be caused by production of a toxic or immunogenic intermediate. On the other hand, inhibition of cyclin-dependent kinases 4 and 6 may also affect hepatocytes and have direct toxicity. Because it is a substrate for CYP 3A4, abemaciclib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

The product label for abemaciclib recommends prospective monitoring of liver tests during therapy, with values obtained before starting, at 2-week intervals during the first two cycles and at the beginning of the ensuing 4 cycles, and "as clinically indicated" thereafter. The product label also provides careful recommendations for dose interruption, reduction or discontinuation based upon toxicities (neutropenia, liver injury, QTc prolongation), with dose interruption until recovery for aminotransferase elevations above 3 times ULN, interruption until normal and subsequent dose reduction if above 5 times ULN, and permanent discontinuation if above 20 times ULN or in the presence of ALT elevations and jaundice. There appears to be minimal cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between abemaciclib and ribociclib or palbociclib or other cyclin-dependent kinase inhibitors. However, switching to these agents should be done with careful monitoring of liver tests.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Cyclin-Dependent Kinase Inhibitor Drugs: Palbociclib, Ribociclib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Abemaciclib – Verzenio®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Abemaciclib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Abemaciclib | 1231929-97-7 | C27-H32-F2-N8

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2026

Abbreviations: ER, estrogen receptor [also referred to as HR, hormone receptor]; HER2, human epidermal growth factor receptor-2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors including abemaciclib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not palbociclib or ribociclib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Patnaik A, Rosen LS, Tolaney SM, Tolcher AW, Goldman JW, Gandhi L, Papadopoulos KP, et al. Efficacy and safety of abemaciclib, an inhibitor of CDK4 and CDK6, for patients with breast cancer, non-small cell lung cancer, and other solid tumors. Cancer Discov 2016; 6: 740-53. (Among 225 patients with various solid tumors treated with escalating doses of abemaciclib, the maximum tolerated dose was 200 mg twice daily and highest response rates [31%] were in women with ER+ breast cancer and adverse events were frequent including diarrhea [63%], nausea [45%] and fatigue [41%]; no mention of ALT elevations or hepatotoxicity). 27217383
Dickler MN, Tolaney SM, Rugo HS, Cortés J, Diéras V, Patt D, Wildiers H, et al. MONARCH 1, A phase II study of abemaciclib, a CDK4 and CDK6 inhibitor, as a single agent, in patients with refractory HR(+)/HER2(-) metastatic breast cancer. Clin Cancer Res 2017; 23: 5218-24. (Among 132 women with refractory, ER+, HER2- metastatic breast cancer treated with abemaciclib [200 mg twice daily] for up to 12 months, the objective response rate was 20% and adverse events were frequent including diarrhea [90%], fatigue [65%], nausea [64%], anorexia [46%] and ALT elevations [30%] which were above 5 times the ULN in 3.8%]). 28533223
Sledge GW Jr, Toi M, Neven P, Sohn J, Inoue K, Pivot X, Burdaeva O, et al. MONARCH 2: Abemaciclib in combination with fulvestrant in women with HR+/HER2- advanced breast cancer who had progressed while receiving endocrine therapy. J Clin Oncol 2017; 35: 2875-84. (Among 669 women with refractory, ER+, HER2- metastatic breast cancer treated with fulvestrant in combination with abemaciclib or placebo, progression-free survival was greater with abemaciclib [16 vs 9 months] but adverse events were also greater including diarrhea [86% vs 25%], neutropenia [46% vs 4%], nausea [45% vs 23%], fatigue [40% vs 27%], ALT elevations [41% vs 32%], and ALT levels above 5 times ULN [4.5% vs 1.4%]). 28580882
Goetz MP, Toi M, Campone M, Sohn J, Paluch-Shimon S, Huober J, Park IH, et al. MONARCH 3: abemaciclib as initial therapy for advanced breast cancer. J Clin Oncol 2017; 35: 3638-46. (Among 493 women with HR+, HER2- advanced breast cancer treated with an aromatase inhibitor and either abemaciclib or placebo, the objective response rate was higher with abemaciclib [59% vs 44%] as were adverse events including diarrhea [81% vs 30%], neutropenia [41% vs 2%], fatigue [40% vs 32%], infections [39% vs 29%], ALT elevations [16% vs 15%] and ALT levels above 5 times ULN [6% vs 2%]). 28968163
Kim ES. Abemaciclib: first global approval. Drugs 2017; 77: 2063-70. (Review of the development, mechanism of action, clinical efficacy and safety of abemaciclib for advanced ER+, HER2- breast cancer). 29128965
Spring LM, Zangardi ML, Moy B, Bardia A. Clinical management of potential toxicities and drug interactions related to cyclin-dependent kinase 4/6 inhibitors in breast cancer: practical considerations and recommendations. Oncologist 2017; 22: 1039-48. (Review of the adverse side effects of palbociclib, ribociclib and abemaciclib and their management, including recommendations for monitoring liver tests and product label recommendations on dose adjustments for liver test abnormalities). 28706010
Fuentes-Antrás J, de Luna A, López de Sá A, Ocaña A, García-Sáenz JÁ, Moreno F. Safety and efficacy of cyclin-dependent kinase inhibitor rechallenge following ribociclib-induced limiting hypertransaminasemia. Breast. 2020;54:160-163. (Among 64 patients with metastatic breast cancer treated with ribociclib, 7 [11%] developed ALT or AST elevations above 5 times the upper limit of normal (ULN), 6 of whom were subsequently treated with either palbociclib [n=5] or abemaciclib [n=1], none of whom had recurrence of aminotransferase elevations). 33096323
Taniguchi A, Kittaka N, Kanaoka H, Nakajima S, Oyama Y, Seto Y, Soma AI, et al. Risk of abemaciclib-induced liver injury in hormone receptor-positive, Her2-negative metastatic breast cancer: a retrospective analysis. Anticancer Res. 2022;42:6027-6035. (Among 52 patients with metastatic breast cancer treated with abemaciclib and hormonal therapy, 15 [29%] developed aminotransferase elevations usually within 3 months, 12 requiring discontinuation, only 4 with ALT above 5 times ULN, and none with bilirubin elevations). 36456126
Ozawa Y, Fujimiya T, Shimada A, Okazawa A, Kusano J, Yamamoto R, Hyasashi S. Successful continuance of CDK4/6 inhibitor treatment with palbociclib after abemaciclib-induced hepatotoxicity in breast cancer: a case report. Anticancer Drugs. 2024;35:89-92. (73 year old woman with metastatic breast cancer developed rash followed by liver test abnormalities 2-4 weeks after starting abemaciclib and fluvestrant [ALT 1073 U/L, GGT 46 U/L, bilirubin 1.4 mg/dL] which improved rapidly upon stopping and remained in the normal range when she was later treated with fluvestrant and palbociclib). 37578747
Meunier L, De Martin E, Delire B, Jacot W, Guiu S, Zahhaf A, Larrey D, et al. CDK4/6 inhibitor-induced liver injury: clinical phenotypes and role of corticosteroid treatment. JHEP Rep. 2024;6:101098. (Among 22 cases women with metastatic breast cancer who developed hepatitis during therapy with either ribociclib [n=19] or abemaciclib [n=3], 18 were asymptomatic and 2 were jaundiced, the injury arising after a mean of 44 days [range 8 to 126 days] with initial mean ALT 563 U/L, Alk P 89 U/L, and bilirubin 0.7 mg/dL (range 0.4 to 1.4 mg/dL, all recovered and 3 later tolerated starting a different CDK4/6 inhibitor [palbociclib or abemaciclib]). 38961854
İlhan N, Baş S, Alkan O, Doğan A, Majidova N, Tunç MA, Erdemoğlu E, et al. Management of hepatotoxicity associated with CDK4/6 inhibitors and rechallenge strategies in metastatic hormone-positive, her2-negative breast cancer. J Cancer Res Clin Oncol. 2025;151:270. (Among 544 patients with metastatic breast cancer treated with ribociclib [n=312] or palbociclib [n=132] between 2017 and 2024 in Turkish oncology centers, 54 [10.5%] developed hepatitis at a mean of 83 [range 33 to 322] days after starting, median peak ALT levels 150 U/L, GGT 67 U/L, bilirubin 0.7 mg/dL, 83% asymptomatic, only 1 with jaundice, many managed with dose adjustment, none fatal or requiring “intervention”, and of 11 switched from ribociclib to palbociclib only 1 had recurrent enzyme elevations). 41014426
Takada S, Umehara K, Watanabe K. Management of severe abemaciclib-induced liver dysfunction: feasibility of switching to palbociclib. In Vivo. 2026;40:532-537.41482396
(5 Japanese women with metastatic breast cancer developed ALT elevations [241 to 1361 U/L] after 27 to 58 days of therapy with abemaciclib, which improved upon stopping, recurred in one patient rechallenged with abemaciclib, but all 5 later tolerated palbociclib without recurrence). Ando Y, Watanabe T, Suzuki T, Hashimoto H, Kuroda T, Iwatani T, Oike N, et al. Characteristic hepatic atrophy in abemaciclib-induced liver injury: a comparative review of three cases. Hepatol Res. 2026 Mar 3. Epub ahead of print. PMID: 41776835
(Three Japanese women with metastatic breast cancer and multiple courses of chemotherapy developed severe liver injury 2 months after starting abemaciclib with hepatic atrophy on CT scan and a loop of bowel between the liver and diaphragm [bilirubin 18.9, 7.0 and 5.8 mg/dL, ALT 848, 1363, and 1400 U/L, Alk P 117, 117 and 188 U/L, INR 1.5, 1.4, and 1.3] the first patient dying of hepatic failure on day 25, second recovering after 165 days, and one recovering within 3 weeks).

## OTHER REFERENCE LINKS

1. Recent References on Abemaciclib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Abemaciclib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Abemaciclib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Abemaciclib)